# Caplacizumab

## OVERVIEW

### Introduction

Caplacizumab is a humanized single variable domain immunoglobulin (nanobody) against the von Willebrand factor, which is used to treat acquired thrombotic thrombocytopenic purpura. Caplacizumab increases the risk of minor and major bleeding episodes and is associated with a low rate of serum aminotransferase elevations during therapy, but has not been linked to instances of clinically apparent liver injury.

### Background

Caplacizumab (cap” la siz’ ue mab) is a humanized single variable domain of immunoglobulin (nanobody) directed against the von Willebrand factor which has been developed as therapy of acquired thrombotic thrombocytopenic purpura (TTP). Acquired TTP is a rare but severe and often fatal syndrome marked by appearance of thrombocytopenia, hemolytic anemia, and multiple microvascular thromboses, with kidney, heart and renal dysfunction due to the development of autoantibodies against ADAMTS13, a vWF cleaving metalloprotease that controls platelet aggregation by vWF. The deficiency in ADAMTS13 results in formation of large platelet-vWF aggregates that cause the pathologic thromboses. Therapy of aTTP generally involves emergency plasma exchange transfusions to reduce levels of the pathogenic autoantibody as well as immunosuppression (usually high doses of corticosteroids or rituximab) to decrease the autoantibody production. Caplacizumab binds to activated vWF and decreases thrombus formation allowing for increases in plasma ADAMTS13 activity. In several small randomized controlled trials, caplacizumab therapy was associated with elevations in serum ADAMTS13, a shorter time to clinical response (rise in platelet counts) and fewer complications, exacerbations and relapses of TTP. Caplacizumab was approved in the United States for use in combination with plasma exchange therapy in patients with acquired TTP in 2019. The recombinant “nanobody” is available in vials of 11 mg per mL under the brand name Cablivi. Administration of caplacizumab is timed with the plasma exchange procedures, generally given initially as an intravenous infusion of 11 mg before the first plasma exchange, followed by 11 mg subcutaneously at the conclusion of each plasma exchange; after the plasma exchange period, 11 mg subcutaneously once daily for 30 days. Common side effects include local infusion reactions, headaches and fatigue, but most characteristically bleeding episodes, typically epistaxis, bruising and gingival and rectal bleeding. Severe adverse events include serious bleeding episodes such as subarachnoid and intracerebral hemorrhage which can be fatal. Early recognition and prompt management of these side effects is an integral component of proper use of caplacizumab.

### Hepatotoxicity

Mild-to-moderate serum aminotransferase elevations arise in 1% to 2% of treated patients, but are generally asymptomatic and transient and rarely necessitate discontinuation of caplacizumab injections. Serum ALT elevations above 5 times the upper limit of normal (ULN) occurred in less than 1% of patients in registration trials of caplacizumab but there were no instances of clinically apparent liver injury. Since approval and more general use of caplacizumab, there have been no reports of clinically significant liver injury attributed to its use.

Likelihood score: E (unlikely cause of clinically apparent acute liver injury).

### Mechanism of Injury

The possible mechanisms of liver injury due to caplacizumab are unclear unless they might be caused by excessive bleeding. Monoclonal antibodies and immunoglobulins are generally taken up by cells and metabolized to short peptides and amino acids.

Drug Class: Monoclonal Antibodies, Hematologic Agents

## PRODUCT INFORMATION

REPRESENTATIVE TRADE NAMES

Caplacizumab – Cablivi®

DRUG CLASS

Hematologic Agents

COMPLETE LABELING (https://dailymed.nlm.nih.gov/dailymed/search.cfm?labeltype=all&query=Caplacizumab)

Product labeling at DailyMed, National Library of Medicine, NIH

## CHEMICAL FORMULA AND STRUCTURE

DRUG | CAS REGISTRY NO. | MOLECULAR FORMULA | STRUCTURE
Caplacizumab | 915810-67-2 | Single Variable Domain Immunoglobulin | Not Available

## ANNOTATED BIBLIOGRAPHY

References updated: 07 June 2021

Abbreviations used: TTP, thrombotic thrombocytopenic purpura; vWF, von Willebrand factor.

Wellstein A, Giaccone G, Atkins MB, Sausville EA. Pathway-targeted therapies: monoclonal antibodies, protein kinase inhibitors, and various small molecules. In, Brunton LL, Hilal-Danan R, Knollman BC, eds. Goodman & Gilman's the pharmacological basis of therapeutics. 13th ed. New York: McGraw-Hill, 2018, pp. 1203-36. (Textbook of pharmacology and therapeutics).
Peyvandi F, Scully M, Kremer Hovinga JA, Cataland S, Knöbl P, Wu H, et al. (2016). TITAN Investigators. Caplacizumab for acquired thrombotic thrombocytopenic purpura. N Engl J Med. (Among 75 patients with acquired TTP treated with caplacizumab or placebo, the time to response was shorter with the caplacizumab and exacerbations were fewer while the bleeding episodes were more frequent [54% vs 38%], while other adverse events were uncommon and mild, ALT elevations arose in 2 [6%] on caplacizumab and none on placebo).
Duggan S. (2018). Caplacizumab: first global approval. Drugs. (Review of the structure, mechanism of action, clinical efficacy and safety of caplacizumab shortly after its approval by the European Medicines Administration as therapy of acquired TTP).
Scully M, Cataland SR, Peyvandi F, Coppo P, Knöbl P, Kremer Hovinga JA, et al. (2019). HERCULES Investigators. Caplacizumab treatment for acquired thrombotic thrombocytopenic purpura. N Engl J Med. (Among 145 patients with acquired TTP treated with caplacizumab or placebo during plasma exchange and for 30 days afterwards, time to platelet normalization, duration of hospitalization, plasma exchange sessions, thrombotic events, and recurrences were less with caplacizumab, while mucocutaneous bleeding episodes were more frequent [65% vs 48%]; no mention of ALT elevations or hepatotoxicity).
Kaczmarek V, Holle J, Astudillo R, Kempf C, Bufler P, Müller D. (2019). Caplacizumab for relapsing thrombotic thrombocytopenic purpura. Pediatr Nephrol. (10 year old girl with recurrent acquired TTP was treated with caplacizumab in addition to plasma exchange during the second episode and, unlike with the first, had a rapid and complete response within 3 days that was sustained without evidence of adverse events).
Chander DP, Loch MM, Cataland SR, George JN. (2019). Caplacizumab therapy without plasma exchange for acquired thrombotic thrombocytopenic purpura. N Engl J Med. (63 year old woman and Jehovah’s Witness developed acquired TTP but refused blood transfusions, and was eventually treated with caplacizumab without plasma exchange and had a rapid and complete clinical response with only a single and minor bleeding episode).
Knoebl P, Cataland S, Peyvandi F, Coppo P, Scully M, Kremer Hovinga JA, et al. (2020). Efficacy and safety of open-label caplacizumab in patients with exacerbations of acquired thrombotic thrombocytopenic purpura in the HERCULES study. J Thromb Haemost. (Among 28 patients who had an exacerbation of disease during a placebo controlled trial of caplacizumab therapy of acquired TTP [Scully 2019], who then received open label therapy with the active drug, responses were prompt and only one patient had a relapse after stopping therapy; adverse events included catheter site hemorrhage, headache and epistaxis but there was no mention of ALT elevations or hepatotoxicity).
Völker LA, Kaufeld J, Miesbach W, Brähler S, Reinhardt M, Kühne L, Mühlfeld A, et al. (2020). Real-world data confirm the effectiveness of caplacizumab in acquired thrombotic thrombocytopenic purpura. Blood Adv. (Retrospective data analysis from 60 patients with acquired TTP treated with caplacizumab in 29 medical centers in Germany found that therapy led to rapid response and normal platelet levels within a median of 3 days, only one death [1.4%] and with few serious adverse events [vaginal bleeding in one patient] and no mention of ALT elevations or hepatotoxicity; in 6 instances patients were treated successfully with caplacizumab alone, without exchange transfusions).
Sukumar S, Lämmle B, Cataland SR. (2021). Thrombotic thrombocytopenic purpura: pathophysiology, diagnosis, and management. J Clin Med. (Review of the history of discovery, clinical characterization and elucidation of pathogenesis of acquired and congenital TTP, and description of actions of vWF and ADAMTS13 in coagulation and thrombosis and abnormalities that characterize aTTP with review of current and future directions in its management including use of caplacizumab).

## OTHER REFERENCE LINKS

1 Recent References on Caplacizumab: from PubMed.gov (https://www.ncbi.nlm.nih.gov/sites/entrez?cmd=search&db=pubmed&pubmedfilters=true&term=Caplacizumab+AND+Human%5BMH%5D+AND+(drug+induced+liver+injury+OR+jaundice/CI+OR+bile+duct+diseases/CI+OR+liver/DE+OR+liver+diseases/CI)+AND+(%221900/1/1%22%5BEDat%5D:%222999/12/31%22%5BEDat%5D))
2 Trials on Caplacizumab: from ClinicalTrials.gov (https://clinicaltrials.gov/ct2/results?term=Caplacizumab)